# Terbinafine

## OVERVIEW

### Introduction

Terbinafine is an orally and topically active allylamine fungicidal agent which is used to treat superficial fungal infections of the skin and nails. Oral terbinafine has been clearly linked to rare instances of acute liver injury that can be severe and sometimes fatal.

### Background

Terbinafine (ter' bin a feen) is a synthetic allylamine derivative that has potent activity against many dermatophytes that affect skin and nails, including Epidermophyton floccosum, Trichophyton mentagrophytes, and Trichophyton rubrum. The antifungal activity of terbinafine is believed to be due to the selective inhibition of fungal squalene epoxidase, which increases squalene to toxic levels, thus killing the fungal cell. Terbinafine was approved for use in the United States in a topical form in 1992 and as an oral antifungal agent in 1998. Topical terbinafine is available over-the-counter as a 1% cream or spray for treatment of dermatophyte infections of the skin (tinea pedis, cruris or corporis). Oral terbinafine is available by prescription only in tablets of 250 mg generically and under the brand name of Lamisal. Oral terbinafine is used in the therapy of onychomycosis or fungal infections of the fingernails or toenails (tinea unguium) typically in a dose of 250 mg once daily for 6 weeks (fingernails) or 12 weeks (toenails). The most common side effects of oral terbinafine include dyspepsia, diarrhea, flatulence, nausea, abdominal pain, change in taste and smell, headache, pruritus, and rash. Rare but potentially severe adverse reactions include neutropenia, liver injury, severe skin rash including exfoliative dermatitis, drug reaction with eosinophilia and systemic symptoms (DRESS), and Stevens Johnson syndrome.

### Hepatotoxicity

Oral therapy with terbinafine is a well-known cause of acute liver injury that can be severe and even fatal. In addition, terbinafine therapy is associated with transient elevations in serum aminotransferases, occurring in less than 1% of patients which are generally asymptomatic and short-lived even without stopping therapy. The estimated probability of developing elevated serum aminotransferase levels requiring stopping treatment is about 0.3% for 2 to 6 weeks of treatment and 0.4% for treatment longer than 8 weeks.

Clinically apparent liver injury from terbinafine is rare (1 in 2,500 to 1:25,000 persons exposed), but many case reports and even case series have been described in the literature. Liver injury usually arises within the first 6 weeks of therapy. The pattern of injury can be either hepatocellular or mixed initially but it typically evolves into a cholestatic pattern which can be prolonged (Cases 1 and 2). Some cases may progress to vanishing bile duct syndrome. Signs of hypersensitivity (rash, fever, eosinophilia) are not common and, when present, are generally mild-to-moderate in severity. Autoantibody formation is rare. In addition, cases with severe hepatocellular injury with acute liver failure have been described. These instances are marked by precipitous onset with marked elevations in serum aminotransferase levels and progressive jaundice and hepatic failure. Terbinafine has also been implicated in cases of Stevens-Johnson syndrome, in which case the hepatic injury may be overshadowed by rash and allergic symptoms.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The acute hepatotoxicity caused by terbinafine appears to be part of a hypersensitivity reaction, although the mechanism has not been defined. Genome-wide association studies identified polymorphisms within the HLA region of chromosome six to be linked to cholestatic cases of drug induced liver injury, and particularly terbinafine. HLA sequencing has confirmed these associations and shown that most subjects of European ancestry with terbinafine hepatotoxicity are carriers of HLA-A* 33:01 (heterozygosity), an allele found in less than 1% of control populations. The HLA-A* 33:03 allele which shares 99% sequence identity with 33:01 has been linked to terbinafine hepatotoxicity in a small number of Asian subjects. These associations indicate that the injury is probably immunologically mediated.

### Outcome and Management

The product label for terbinafine contains a warning about hepatotoxicity from its use and recommends testing for routine liver tests before starting and at intervals during therapy. Terbinafine should be promptly discontinued if evidence of liver injury arises during treatment. Most cases of acute hepatic injury from terbinafine resolve within 3 to 6 months of stopping the medication. In some instances, however, the injury is severe and unremitting, leading to acute liver failure and either death or need for liver transplantation. A severe outcome is more likely if terbinafine is continued after the appearance of symptoms and signs of liver injury. Terbinafine has also been implicated in several cases of acute bile duct injury, followed by prolonged cholestasis associated with vanishing bile duct syndrome. Perhaps more frequent is severe cholestasis followed by persistence of mild to moderate elevations in alkaline phosphatase without jaundice or symptoms which may represent a mild and partially reversable form of vanishing bile duct syndrome. There appears to be no cross sensitivity to hepatic injury between terbinafine and griseofulvin, another agent used for onychomycosis.

Drug Class: Antifungal Agents

## CASE REPORT

### Case 1. Prolonged cholestasis due to terbinafine.(1)

A 24 year old man developed progressive loss of appetite, pruritus and jaundice within days of stopping a 3½ week course of terbinafine (250 mg daily) for onychomycosis of the toenails. On initial evaluation one week later, he was jaundiced and had excoriations. There was no fever, urticaria or rash. Laboratory tests showed serum bilirubin of 6.6 mg/dL and elevations in both ALT (584 U/L) and alkaline phosphatase (222 U/L). Tests for hepatitis A, B and C were negative, he did not drink alcohol to excess, and he took no other medications. Ultrasound of the abdomen showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis and injury to small bile ducts, with reduction in the number of ducts. Despite having stopped terbinafine, his symptoms and laboratory test abnormalities worsened over the next few weeks. Pruritus was treated with antihistamines and cholestyramine. Six weeks after stopping terbinafine, his symptoms began to improve and 16 weeks after stopping his liver tests were normal (Table).

#### Key Points

Medication: | Terbinafine (250 mg daily)
Pattern: | Hepatocellular→Cholestatic (R=7.5→1.1)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 24 days to symptoms, 32 days to jaundice
Recovery: | Complete recovery after 12 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
1 month | 8 days | 584 | 222 | 6.6 | Admission
| 11 days | 420 | 370 | 12.0 | Normal ultrasound
| 21 days | 210 | 530 | 20.5 | Intense pruritus
| 27 days | 190 | 550 | 25.0
| 29 days | 205 | 525 | 30.9 | Liver biopsy
2 months | 5 weeks | 310 | 490 | 28.0
| 6 weeks | 250 | 490 | 21.0 | Symptoms improved
| 7 weeks | 175 | 400 | 10.0
| 8 weeks | 40 | 670 | 5.0
3 months | 9 weeks | | 200 | 1.4 | Asymptomatic
| 10 weeks | 40 | 110 | 0.5
Normal Values | | <42 | <120 | <1.2

*Values estimated from Figure 2.

#### Comment

This was a typical case of terbinafine hepatotoxicity arising within 4 weeks of starting therapy and worsening for several weeks thereafter despite the prompt discontinuation. The initial laboratory results suggested a hepatocellular pattern of injury, but by the time of peak bilirubin elevation the serum enzyme pattern was clearly cholestatic. The prominence of jaundice and pruritus also argued for a cholestatic injury. A liver biopsy showed evidence of injury to bile ducts and ductopenia, which was clearly severe enough to cause prolonged jaundice, but not severe enough to cause persistence of cholestatic features and qualify as vanishing bile duct syndrome.

### Case 2. Terbinafine induced cholestatic hepatitis.(2)

A 43 year old man with history of diabetes and onychomycosis developed fatigue and flu-like symptoms one month after starting treatment with terbinafine taken orally once daily. He developed severe itching one week later and stopped terbinafine after a total of 40 days. Several days later he complained of nausea, vomiting and became jaundiced. Laboratory investigations (Table 1) revealed bilirubin of 6.8 mg/dL, ALT 269 U/L and alkaline phosphatase 433 U/L. Tests for hepatitis A, B and C were negative as were autoantibodies. Imaging of the liver showed no evidence of extrahepatic obstruction. Five days after stopping terbinafine, prednisone was started. Prednisone was initially given intravenously and then orally in tapering doses over 4 weeks (60 mg, 40 mg, 20 mg, 10 mg for one week each). The itching and jaundice improved and he became asymptomatic a month after initial presentation. Liver test abnormalities resolved over the next several months.

#### Key Points

Medication: | Terbinafine
Pattern: | Mixed (R=3.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 34 days
Recovery: | Symptomatic improvements after 4 weeks
Other medications: | Milrinone lactate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | Normal | Normal | Normal
0 | | Terbinafine started
34 days | | | | | Fatigue, flu-like illness
40 days | 0 | Terbinafine stopped | | | Severe itching, dark urine
| 3 days | 269 | 443 | 6.8 | Nausea and vomiting
| 6 days | 234 | 489 | 6.2 | Prednisone started
7 weeks | 7 days | 269 | 508 | 9.1
| 10 days | 686 | 667 | 11.3
2 months | 17 days | 775 | 625 | 6.4
3 months | 1 month | 99 | 232 | 2.1 | Prednisone stopped
Normal Values | | <41 | 115 | <1.2

#### Comment

A 43 year old man developed fatigue approximately 5 weeks after starting terbinafine and itching and jaundice one to two weeks later. The symptoms (itching) suggested a cholestatic hepatitis, although the initial pattern of enzyme elevations was “mixed” (R=3.7). While corticosteroids may improve itching and jaundice, they have not been shown to ameliorate or shorten the course of illness. The patient became asymptomatic after 4 weeks, but was lost to follow up. Follow up is important, as terbinafine hepatotoxicity has been linked to cases of chronic cholestasis and vanishing bile duct syndrome, and his liver tests were not normal when he was last seen and prednisone stopped.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Terbinafine – Generic, Lamisil®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=terbinafine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Terbinafine | 91161-71-6 | C21-H25-N

## CITED REFERENCES

1 Fernandes NF, Geller SA, Fong TL. Terbinafine hepatotoxicity: case report and review of the literature. Am J Gastroenterol 1998; 93: 459-60. 9517658
2 Fontana RJ, Cirulli ET, Gu J, Kleiner D, Ostrov D, Phillips E, Schutte R, et al. The role of HLA-A*33:01 in patients with cholestatic hepatitis attributed to terbinafine. J Hepatol. 2018;69:1317-1325..30138689

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2026

Abbreviations; HLA, human leukocyte antigen; iv, intravenous.

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; reports that terbinafine has been implicated in at least 10 cases of hepatic injury, usually mixed pattern of enzyme elevations and 1 case of possible vanishing bile duct syndrome).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents mentions that many case reports of terbinafine hepatotoxicity have been published, that latency is 4 to 6 weeks, typically with a mixed enzyme pattern, sometimes with bile duct injury and occasionally with acute liver failure).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. xxxxxx. (Textbook of pharmacology and therapeutics mentions that oral terbinafine is more effective than itraconazole for nail onychomycosis).
Lowe G, Green C, Jennings P. Hepatitis associated with terbinafine treatment. BMJ 1993; 306: 248. (52 year old man developed abdominal pain and jaundice 2 weeks after starting terbinafine [bilirubin 1.7 mg/dL, ALT 470 U/L and AlkP 193 U/L], resolving within a month of stopping). 8443524
Hay RJ. Risk/benefit ratio of modern antifungal therapy: focus on hepatic reactions. J Am Acad Dermatol 1993; 29: S50-4. (Review article on hepatotoxicity of antifungal agents, griseofulvin, ketoconazole, fluconazole, itraconazole and terbinafine; does not recommend routine monitoring, but stresses need to discontinue agent if there are symptoms of hepatic injury). 8315062
van ‘t Wout JW, Herrmann WA, de Vries RA, Stricker BHC. Terbinafine-associated hepatic injury. J Hepatology 1994; 21: 1115-7. (Two cases of hepatitis due to terbinafine; 63 year old man and 52 year old woman who developed jaundice 38 and 31 days after starting terbinafine [bilirubin 10.6 and 7.3 mg/dL, ALT 194 and 446 U/L, and Alk P 201 and 296 U/L], resolving slowly but completely by 12 weeks). 7963410
Ihre-Lundgren C, Frisell J, Bergman U. [A patient treated with terbinafine. Intrahepatic biliary stasis is a severe adverse effect]. Lakartidningen 1995; 92: 1112-3. Swedish. PMID: 7700115 (43 year old man developed fatigue and jaundice 6 weeks after starting terbinafine [bilirubin 10.9 mg/dL, ALT 312 U/L, Alk P 690 U/L], worsening for 4 weeks, found to have intrahepatic gallstones, resolving over 12 weeks).
Lazaros GA, Papatheodoridis GV, Delladetsima JK, Tassopoulos NC. Terbinafine-induced cholestatic liver disease. J Hepatol 1996; 24: 753-6. (58 year old woman developed jaundice 7 weeks after starting terbinafine and presented 18 days later with jaundice [bilirubin 16.7 mg/dL, ALT 470 U/L, Alk P 934 U/L], resolving slowly over the 6 months after stopping). 8835752
Boldewijn OY, Ottervanger JP, Mostart CM, Janssens AR, Calame J, Jonkers GJ. [Hepatitis attributed to the use of terbinafine]. Ned Tijdschr Geneeskd 1996; 140: 669-72. Dutch. PMID: 8668241 (71 year old developed severe cholestasis [bilirubin 7.9 mg/dL, ALT 321 U/L] and pruritus that persisted for 10 months, after stopping 6 week course of terbinafine).
Vantaux P, Grasset D, Nougue J, Lagier E, Seigneuric C. [Acute hepatitis related to the ingestion of terbinafine]. Gastroenterol Clin Biol 1996; 20: 402-3. French. PMID: 8758509 (68 year old man developed malaise and fever 23 days after starting terbinafine [bilirubin 1.8 mg/dL, ALT 9 times ULN, Alk P 4 times ULN], with rapid improvement and resolution within 1 month of stopping).
Dwyer CM, White MI, Sinclair TS. Cholestatic jaundice due to terbinafine. Br J Dermatol 1997; 136: 976-7. (40 year old man developed jaundice and pruritus 6 weeks after starting terbinafine [bilirubin 5.6 mg/dL, ALT 165 U/L, Alk P 256 U/L], resolving within 10 weeks of stopping). 9217846
Mallat A, Zafrani ES, Metreau JM, Dhumeaux D. Terbinafine-induced prolonged cholestasis with reduction of interlobular bile ducts. Dig Dis Sci 1997; 42: 1486-8. (75 year old woman developed weakness followed by jaundice and pruritus several days after completing a 3-week course of terbinafine [bilirubin 5.2 rising to 7.3 mg/dL, ALT 277 U/L, Alk P 375 U/L]; pruritus persisted and biopsy at 6 months showed decrease in bile ducts; GGT still abnormal 17 months later). 9246051
Shiloah E, Horowiz M, Zecler E. [Terbinafine-induced cholestatic liver injury]. Harefuah 1997; 133: 11-2, 80-1. Hebrew. PMID: 9332048
Tejada García M, Llvona Hevia AM, Martín Arias L, García-Pando AC. [Terbinafine and cholestatic hepatitis]. Med Clin (Barc) 1997; 109: 356. Spanish. PMID: 9379769 (58 year old man developed jaundice 40 days after starting terbinafine [bilirubin 13.3 mg/dL, ALT 136 U/L, Alk P 728 U/L], 6 months later, he was anicteric but still had mild serum aminotransferase elevations).
Vivas S, Rodríguez M, Palacio MA, Cadenas F, Lomo J, Rodrigo L. [Acute hepatitis associated with terbinafine]. Gastroenterol Hepatol 1997; 20: 456-8. Spanish. PMID: 9445740 (59 year old man developed abdominal pain and dark urine 32 days after starting terbinafine, presenting with jaundice 1 week later [bilirubin 13.3 rising to 37 mg/dL, ALT 136 U/L, Alk P 728 rising to 1258 U/L], with prolonged cholestasis requiring a year for full resolution; seems to be the same case as Tejada Garcia [1997]).
Hall M, Monka C, Krupp P, O'Sullivan D. Safety of oral terbinafine: results of a postmarketing surveillance study in 25,884 patients. Arch Dermatol 1997; 133: 1213-9. (Results of prospective postmarketing surveillance in 25,884 patients treated with terbinafine for an average of 13 weeks; adverse events reported in 10.5%, largely gastrointestinal upset [4.9%] and dermatologic [2.3%]; hepatobiliary events in 55 patients [0.2%], 45 with asymptomatic ALT elevations, 5 with nonspecific symptoms and 5 with jaundice). 9382559
Abdel-Rahman SM, Nahata MC. Oral terbinafine: a new antifungal agent. Ann Pharmacother 1997; 31: 445-56. (Extensive review of clinical efficacy of terbinafine for superficial fungal infections; low rate of adverse events ~2% to 7%, asymptomatic ALT elevations in 0.5%, severe hepatitis in 1:120,000). 9101008
Fernandes NF, Geller SA, Fong TL. Terbinafine hepatotoxicity: case report and review of the literature. Am J Gastroenterol 1998; 93: 459-60. (24 year old man developed jaundice and pruritus 3.5 weeks after starting terbinafine [bilirubin 6.6 rising to 30.9 mg/dL, ALT 584 U/L, Alk P 222 U/L], biopsy showing bile duct injury; resolving within 3 months of stopping). 9517658
Gupta AK, del Rosso JQ, Lynde CW, Brown GH, Shear NH. Hepatitis associated with terbinafine therapy: three case reports and a review of the literature. Clin Exp Dermatol 1998; 23: 64-7. (Three cases, 1 man and 2 women, ages 54, 42 and 74 years, presenting after 3, 4 and 4 weeks with jaundice [bilirubin 8.4, 5.3 and 10.5 mg/dL, ALT 407, 521 and 333 U/L, Alk P 273, 214 and 157 U/L], slow resolution and no or little follow up on two cases). 9692307
Agarwal K, Manas DM, Hudson M. Terbinafine and fulminant hepatic failure. N Engl J Med 1999; 340: 1292-3. (48 year old woman developed acute liver failure after 5 days of terbinafine therapy, ultimately requiring successful emergency liver transplantation; few details given). 10215503
García Rodriguez L, Duque A, Castellsague J, Pérez-Gutthann S, Stricker B. A cohort study on the risk of acute liver injury among users of ketoconazole and other antifungal drugs. Br J Clin Pharmacol 1999; 48: 847-52. (Population based study identified 5 cases of acute liver injury during antifungal therapy in 69,830 patients; relative risk for ketoconazole was 228 (1: 500 patients], itraconazole 17.7 [~1:10,000] and terbinafine 4.2 [~1:50,000]). 10594489
Chambers WM, Millar A, Jain S, Burroughs AK. Terbinafine-induced hepatic dysfunction. Eur J Gastroenterol Hepatol 2001; 13: 1115-8. (41 year old man developed jaundice 4 weeks after starting terbinafine which worsened over next 3 to 6 weeks [bilirubin 7.0 rising to 33.2 mg/dL, AST 124 U/L, Alk P 568 U/L], followed by prolonged jaundice [5 months], pruritus [10 months] and persistent Alk P elevations). 11564966
Conjeevaram G, Vongthavaravat V, Sumner R, Koff RS. Terbinafine-induced hepatitis and pancytopenia. Dig Dis Sci 2001; 46: 1714-6. (63 year old man developed malaise, fever and pancytopenia 4 weeks after starting terbinafine, which worsened over the next 3 weeks [bilirubin 1.7 rising to 2.0 mg/dL, ALT 86 to 1073 U/L, Alk P 94 to 597 U/L], resolving within 6 weeks of stopping). 11508672
Iverson SL, Uetrecht JP. Identification of a reactive metabolite of terbinafine: insights into terbinafine-induced hepatotoxicity. Chem Res Toxicol 2001; 14: 175-81. (Identified an N-dealkylation product of terbinafine which could bind to hepatobiliary proteins and induce an immune reaction). 11258966
Johnstone D, Berger C, Fleckman P. Acute fulminant hepatitis after treatment with rabeprazole and terbinafine. Arch Intern Med 2001; 161: 1677-8. (46 year old man developed jaundice 4 weeks after starting terbinafine, citalopram, and rabeprazole [bilirubin 1.2 rising to 5.2 mg/dL, ALT >3000 U/L, INR 1.8, mild encephalopathy and renal failure], but eventual recovery after stopping all 3 agents). 11434801
Andrade RJ, Lucena MI. Acute fulminant hepatitis after treatment with rabeprazole and terbinafine: is rabeprazole the culprit? Arch Intern Med 2002; 162: 360-1. (Letter in response to Johnstone [2001] suggesting that terbinafine was the culprit rather than rabeprazole). 11822934
Severe liver damage on terbinafine. Prescrire Int 2002; 11: 16. (Mentions that FDA has reported 16 cases of severe liver damage due to terbinafine, including 11 deaths and 2 liver transplants). 11985370
Anania FA, Rabin L. Terbinafine hepatotoxicity resulting in chronic biliary ductopenia and portal fibrosis. Am J Med 2002; 112: 741-2. (56 year old woman with jaundice after a short course of terbinafine who developed persistent pruritus and Alk P elevations [550 U/L], liver biopsy 20 months later showing paucity of bile ducts). 12079721
Walter RB, Lukaschek J, Renner EL, Müllhaupt B, Bachli EB. Fatal hepatic veno-occlusive disease associated with terbinafine in a liver transplant recipient. J Hepatol 2003; 38: 373-4. (35 year old man with familial amyloid polyneuropathy and liver transplant developed jaundice 6 weeks after starting terbinafine [bilirubin 8.9 mg/dL, ALT 491 U/L, Alk P 1128 U/L], with severe pruritus, ascites, progressive central vein sclerosis, and death from gastrointestinal bleeding). 12586307
Zapata Garrido AJ, Romo AC, Padilla FB. Terbinafine hepatotoxicity. A case report and review of the literature. Ann Hepatol 2003; 2: 47-51. (53 year old woman developed jaundice and abdominal pain 7 days after starting terbinafine [bilirubin 5.8 rising to 23 mg/dL, ALT 1272 U/L, Alk P 154 U/L], worsening for 4 weeks and then resolving over the next 4 months after stopping). 15094707
Ajit C, Suvannasankha A, Zaeri N, Munoz SJ. Terbinafine-associated hepatotoxicity. Am J Med Sci 2003; 325: 292-5. (65 year old man developed fatigue and jaundice 4 weeks after starting terbinafine [bilirubin 21.0 mg/dL, ALT 179 U/L, Alk P 1040 U/L], slow recovery, biopsy showing bile duct injury; corticosteroids started and improved, but enzymes were not normal 4 months later). 12792250
Burstein Z, Vildosola H, Lozano Z, Verona R, Vargas G. Colestasic toxic hepatitis caused by terbinafine: case report. Rev Gastroenterol Peru 2004; 24: 357-62. Spanish. PMID: 15614306 (31 year old woman developed jaundice 40 days after starting terbinafine [bilirubin 3.2 mg/dL, ALT 244 U/L, Alk P 334 U/L], resolving within 3 months of stopping).
Wingfield AB, Fernandez-Obregon AC, Wignall FS, Greer DL. Treatment of tinea imbricate: a randomized clinical trial using griseofulvin, terbinafine, itraconazole and fluconazole. Br J Dermatol 2004; 150: 119-26. (Randomized trial of four antifungals for 4 weeks for tinea imbricate in 86 patients in New Guinea; griseofulvin and terbinafine were effective; itraconazole and fluconazole were not; only one patient had ALT elevation [3-fold: terbinafine]). 14746625
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 6 were attributed to ketoconazole and 1 to itraconazole, but none to terbinafine). 15390328
Nakano N, Hiruma M, Shiraki Y, Chen X, Porgpermdee S, Ikeda S. Combination of pulse therapy with terbinafine tablets and topical terbinafine cream for the treatment of dermatophyte onychomycosis: a pilot study. J Dermatol 2006; 33: 753-8. (Trial of pulse therapy with terbinafine in 66 patients [one week every month] found high rate of response and “no abnormal findings in the laboratory tests performed before, during or after pulse therapy”). 17073989
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; terbinafine reported to cause ALT elevations in 4% of patients; several cases of clinically apparent hepatitis and acute liver failure have been described, typically arising within 4-6 weeks and requiring 3-6 months to resolve; 16 cases of hepatotoxicity reported to FDA, including 11 deaths and 2 liver transplants). 15751740
Paredes AH, Lewis JH. Terbinafine-induced acute autoimmune hepatitis in the setting of hepatitis B virus infection. Ann Pharmacother 2007; 41: 880-4. (57 year old male HBsAg carrier who developed severe acute hepatitis after 12 weeks of terbinafine therapy [bilirubin 11.0 mg/dL, ALT 1044 U/L, Alk P 167 U/L] and rise in HBV DNA; suggestive of HBV reactivation rather than terbinafine hepatotoxicity per se). 17426078
Kim B, Jang H, Jwa S, Jang B, Kim M, Oh C, Kwon Y, et al. Generalized pustular psoriasis and hepatic dysfunction associated with oral terbinafine therapy. J Korean Med Sci 2007; 22: 167-9. (61 year old man with psoriasis developed generalized pustular psoriasis 4 days after starting terbinafine with fever, rash, and neutrophilia but no jaundice [bilirubin normal, ALT 376 U/L, Alk P 564 U/L], symptoms and enzyme elevations responding to corticosteroids within 2 weeks). 17297275
Chang CH, Young-Xu Y, Kurth T, Orav JE, Chan AK. The safety of oral antifungal treatments for superficial dermatophytosis and onychomycosis: a meta-analysis. Am J Med 2007; 120: 791-8. (The pooled probability of stopping terbinafine because of elevated ALT/AST was 0.31% [95% CI, 0%-0.74%] for 2-6 weeks and 0.44% [95% CI, 0.13%-0.76%] for 8-48 weeks). 17765049
Perveze Z, Johnson MW, Rubin RA, Sellers M, Zayas C, Jones JL, Cross R, et al. Terbinafine-induced hepatic failure requiring liver transplantation. Liver Transpl 2007; 13: 162-4. (50 year old man developed jaundice 3 months after starting terbinafine [bilirubin 29 rising to 67.7 mg/dL, ALT 149 U/L, Alk P 497 U/L], with progressive hepatic failure leading to liver transplantation, explant showed severe cholestasis and paucity of bile ducts). 17192859
Gendre G, Buclin T, Morard I, Fontannaz J, Berney JL. [Terbinafine induced hepatitis with persistent cholestasis]. Rev Med Suisse 2008; 4: 736-9. French. PMID: 18472735 (55 year old developed jaundice 6 weeks after starting terbinafine [bilirubin 11.9 mg/dL, ALT 57 U/L, Alk P 590 U/L], jaundice persisting for 3 months and Alk P elevations continuing for more than 6 months, biopsy showing vanishing bile duct syndrome).
Elewski BE, Cáceres HW, DeLeon L, El Shimy S, Hunter JA, Korotkiy N, Rachesky IJ, et al. Terbinafine hydrochloride oral granules versus oral griseofulvin suspension in children with tinea capitis: results of two randomized, investigator-blinded, multicenter, international, controlled trials. J Am Acad Dermatol 2008; 59: 41-54. (Pooled analysis of two controlled trials of 6 weeks of terbinafine vs griseofulvin in 1549 children with tinea capitis; no difference in biochemical laboratory results between two groups; low rate of discontinuation because of abnormal liver tests [<1%]). 18378354
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antifungal agents, including 4 to terbinafine, 2 to fluconazole, 1 each to ketaconazole and itraconazole). 18955056
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; because of risk of liver injury from terbinafine, recommends that liver tests be assessed before and periodically during therapy). 19940816
Gupta AK, Lynch LE, Kogan N, Cooper EA. The use of an intermittent terbinafine regimen for the treatment of dermatophyte toenail onychomycosis. J Eur Acad Dermatol Venereol 2009; 23: 256-62. (Trial comparing continuous vs intermittent terbinafine for onychomycosis in 142 adults reported no serious adverse events; no mention of liver toxicity). 19438818
Takahata Y, Hiruma M, Shiraki Y, Tokuhisa Y, Sugita T, Muto M. Treatment of dermatophyte onychomycosis with three pulses of terbinafine (500 mg day for a week). Mycoses 2009; 52: 72-6. (55 patients with onychomycosis were treated with 3 one-week courses [pulses] of terbinafine; no patient had “abnormal findings in any of the laboratory tests”). 18444971
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; terbinafine was not listed in the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 6 were due to antifungal agents, including 3 to terbinafine). 20949552
Tey HL, Tan AS, Chan YC. Meta-analysis of randomized, controlled trials comparing griseofulvin and terbinafine in the treatment of tinea capitis. J Am Acad Dermatol 2011; 64: 663-70. (Systematic review of trials comparing oral griseofulvin and terbinafine, rates of hepatotoxicity not mentioned, but authors do not recommend routine monitoring of liver tests if terbinafine is given for 4 weeks only). 21334096
Deng S, Hu H, Abliz P, Wan Z, Wang A, Cheng W, Li R. A random comparative study of terbinafine versus griseofulvin in patients with tinea capitis in western China. Mycopathologia 2011; 172: 365-72. (88 children with tinea capitis were treated with 2-4 weeks of oral terbinafine or grisefulvin; reported that there were no side effects). 21701791
Antifungal drugs. Treat Guidel Med Lett 2012; 10 (120): 61-8. (Concise summary of recommendations and guidelines for use of antifungal drugs including the imidazoles and triazoles, echinocandins, terbinafine, flucytosine, and amphotericin; liver adverse events are mentioned for terbinafine, ketoconazole, fluconazole, itraconazole, posaconazole and voriconazole). 22825657
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral antifungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, only 2 of which were attributed to terbinafine). 23750489
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to terbinafine or other antifungal agents). 23419359
Choudhary NS, Kotecha H, Saraf N, Gautam D, Saigal S. Terbinafine induced liver injury: a case report. J Clin Exp Hepatol 2014; 4: 264-5. (55 year old man developed jaundice and pruritus 1 month after starting terbinafine [bilirubin 13.6 mg/dL, ALT 216 U/L, Alk P 202 U/L], resolving within 3 months of stopping and with ursodiol therapy). 25755569
Kumar K, Gill A, Shafei R, Wright JL. A curious case of cholestasis: oral terbinafine associated with cholestatic jaundice and subsequent erythema nodosum. BMJ Case Rep 2014; 2014. PMID: 25480138 (A 30ish year old woman developed itching and jaundice shortly after completing a 3 week course of terbinafine [bilirubin 8.5 mg/dL, ALT 120 U/L, Alk P 463 U/L] followed by erythema nodosum which was treated with prednisone; 6 weeks later the skin rash had resolved and all liver tests were normal).
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of spontaneous reports of drug induced liver injury to the FDA between 2004 and 2011 identified 395 cases of liver injury attributed to terbinafine including 27 cases of acute liver failure, thus ranking first in total number of cases due to antifungal agents). 25232453
Yan J, Wang X, Chen S. Systematic review of severe acute liver injury caused by terbinafine. Int J Clin Pharm 2014; 36: 679-83. (Case report and systematic review of the literature on liver injury from terbinafine; 45 year old man developed dark urine 2 weeks after starting terbinafine and was admitted one month later [bilirubin 18.9 mg/dL, ALT 580 U/L, Alk P not provided] with eventual full recovery after treatment with ursodiol and several traditional Chinese medications). 24986266
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to terbinafine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US mulitcenter prospective study between 2004 and 2013, 7 [0.9%] were attributed to terbinafine). 25754159
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents discusses terbinafine and its association with both hepatocellular and cholestatic jaundice and which can result in acute liver failure). 27927037
Kramer ON, Albrecht J. Clinical presentation of terbinafine-induced severe liver injury and the value of laboratory monitoring: a critically appraised topic. Br J Dermatol 2017; 177: 1279-84. (Among 38 publications describing clinical features of terbinafine induced liver injury, 173 cases were analyzed but only 31 with jaundice, mean age of 54 years [range 24-75], mean latency to onset was 33 days [range 5-84], 3 patients died and 3 underwent liver transplantation; the authors conclude that routine monitoring of liver tests is not justified and is unlikely to be beneficial). 28762471
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017; 152: 1078-89. (A genome-wide association study done on 862 persons of European ancestry with drug induced liver injury demonstrated a highly significant association with a polymorphism on chromosome 6 which was a proxy for HLA-A* 33:01 and most strongly linked to cases of terbinafine, although also with fenofibrate, methyldopa, and ticlopidine and possibly other drug causes of cholestatic injury). 28043905
Kaushal M, Tolani P, Kumar N, Sharma S. Terbinafine-induced liver injury. Natl Med J India. 2017;30:321-323.. (64 year old Indian man developed jaundice 20 days after starting terbinafine [bilirubin 18 mg/dL, ALT 408 U/L, Alk P 990 U/L] with jaundice lasting 2 months but ultimate resolution except for minor Alk P elevation at 3 months). 30117442
Fontana RJ, Cirulli ET, Gu J, Kleiner D, Ostrov D, Phillips E, Schutte R, et al. The role of HLA-A*33:01 in patients with cholestatic hepatitis attributed to terbinafine. J Hepatol. 2018;69:1317-1325.. (Among 1260 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2004 and 2017, 15 [1.2%] cases were attributed to terbinafine, all of whom were above the age of 40 years, 80% were jaundiced, and median latency to onset was 38 days; the extended HLA haplotype A*33:01-B*14:02-C*08:02 was found in 11 patients including 10 of 11 European ancestry [91%] versus 1% of controls; and 2 East Asian patients had a related HLA type [A*33:03]). 30138689
Mejías Manzano MLÁ, Giráldez Gallego Á, Ontanilla Clavijo G, Sousa Martín JM. Terbinafine-induced hepatotoxicity. Gastroenterol Hepatol. 2019;42:394-395. English, Spanish. PMID: 31167724. (47 year old woman with ankylosing spondylitis developed jaundice 3 weeks after stopping a 28-day course of terbinafine [bilirubin 3.5 mg/dL, ALT 572 U/L, Alk P 896 U/L] with persistent mild abnormalities of ALT and Alk P levels still present for 9 months).
Carnio LR, Johnson Shaw ME, Schnur J, Casadesus D. Concurrent terbinafine-induced acute generalised exanthematous pustulosis and hepatitis. BMJ Case Rep. 2021;14:e238930.. (55 year old woman developed rash within a week of starting terbinafine that worsened despite use of oral corticosteroids [bilirubin not given, ALT 770 U/L, Alk P 169 U/L] with rapid improvement in both rash and serum enzyme elevations upon use of iv dexamethasone). 33462036
Ley D, Musto J, Said A. A case of progressive cholestatic drug-induced liver injury due to terbinafine. WMJ. 2023;122:138-142.. (62 year old woman with multiple comorbidities developed fatigue and jaundice 41 days after starting terbinafine [bilirubin 41.4 mg/dL, ALT 245 U/L, Alk P 1494 U/L] with renal failure requiring temporary dialysis but slow incomplete recovery at 6 months [bilirubin 0.9 mg/dL, ALT 105 U/L, Alk P 480 U/L] and persistence of Alk P elevations [520 U/L] 2 years later). 37141482
Jilani M, Zaidi S, Cazares Parson M, Brockman MJ, Hakim N, Edwards BP. Terbinafine-induced liver injury: a case report. Cureus. 2023;15:e50749.. (70 year old Hispanic female developed jaundice and fatigue 5 weeks after starting terbinafine and 1 month later remained jaundiced [bilirubin 24.5 mg/dL, ALT 64 U/L, Alk P 238 U/L] and she had improved but was still jaundiced when last seen 6 weeks later [bilirubin 4.5 mg/dL]). 38239534
Brown A, Potesta M, Hameed A. Drug-induced liver injury secondary to terbinafine use. Cureus. 2024;16:e54453.. (41 year old African American prisoner developed jaundice while taking terbinafine [bilirubin 32 mg/dL, ALT 832 U/L, Alk P 1843 U/L] with moderate improvement with prednisone therapy bit scant follow up). 38510874
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, at a rate of 1 per 25,000 patients exposed to terbinafine). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 20 cases of due to terbinafine which was estimated as an incidence of 1 per 2,600 persons treated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 4 [1%] were attributed to terbinafine). 38992407
Hill RC, Lipner SR. Asymptomatic hepatotoxicity following exposure to oral terbinafine for onychomycosis treatment. Dermatol Online J. 2025;31.. (82 year old woman developed dark urine 27 days after starting terbinafine with bilirubin 0.7 rising to a peak of 1.5 mg/dL, ALT 225 to 304 to U/L, Alk P 191 to 363 U/L, which were normal 4 months later). 40526934
Wenk KS, Wu X, Miller MJ. Infrequent laboratory abnormalities during terbinafine therapy for onychomycosis: A retrospective cohort analysis within an integrated health system. J Am Acad Dermatol. 2025;92:1080-1082.. (Analysis of medical records of 13,399 treatment courses of terbinafine, identified only 9 instances of possible liver injury with ALT elevations in 0.36% ranging from 119 to 643 U/L, Alk P elevations in 0.18% ranging from 193 to 480 U/L, only one can with symptoms and bilirubin elevation [1.6 mg/dL] and none scored as severe). 37717727

## OTHER REFERENCE LINKS

1. Recent References on Terbinafine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(terbinafine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Terbinafine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=terbinafine)